# Hepatitis C (HCV) Agents

## OVERVIEW

The hepatitis C virus (HCV) is a small RNA virus belonging to the family flaviviridae and genus hepacivirus. The virion is approximately 50 nm in diameter and has an outer lipid associated envelop (E1 and E2) and inner nucleocapsid (Core). Within the nucleocapsid is a single molecule of single-stranded RNA of positive polarity approximately 9.5 kilobases in length. The RNA is transcribed into a large polyprotein that is subsequently cleaved into multiple polypeptides, labeled from the 5’ to 3’ end: core, envelope 1 and 2, and nonstructural proteins NS2, NS3, NS4 and NS5A and NS5B. The NS3 region encodes a viral helicase and protease. The NS5A region encodes a polypeptide that is essential for production and maintenance of the replicative complex. The NS5B region encodes a viral RNA dependent, RNA polymerase that is essential for replication. The NS3, NS5A and NS5B regions have been targeted with direct acting antiviral agents.

The initial agents used to treat chronic hepatitis C were interferon alfa, peginterferon and ribavirin. The antiviral activity of interferon and peginterferon is based upon their ability to stimulate interferon stimulated genes (ISGs) that have endogenous antiviral activities. Ribavirin is a nucleoside analogue that potentiates the effects of interferon against hepatitis C by as yet undefined mechanisms. Until 2010, the standard therapy of chronic hepatitis C was the combination of peginterferon and ribavirin given for 24 or 48 weeks. This combination led to sustained clearance of HCV and remission in disease in 40% to 50% of patients. Response rates were higher with certain HCV genotypes, so that response rates in patients with genotypes 2 and 3 were as high as 70% to 80%. Importantly, these remissions in disease have been shown to represent cure of the chronic viral infection, in that long term follow up demonstrated lack of HCV replication and resolution of disease activity in over 98% of patients. The shortcomings of peginterferon-ribavirin therapy were significant, most importantly the poor tolerance and side effects of this regimen. Thus, a high proportion of patients was intolerant or had contraindications to treatment. In 2010, three HCV-specific protease inhibitors were approved for use and introduced into practice: boceprevir, telaprevir and simeprevir. All three of these were specific to genotype 1 HCV and had little or no activity against genotypes 2 or 3 or the lesser common genotypes 4, 5 and 6. Triple therapy with peginterferon, ribavirin and a HCV-specific protease inhibitor (boceprevir, telaprevir or simeprevir) increased the response rate in patients with chronic hepatitis C, genotype 1 from 40%-45% to 65%-75%. A persistent difficulty, however, was the continued need to combine these agents with peginterferon and the considerable side effects which were worsened by these protease inhibitors.

An important advance in therapy of hepatitis C came in 2013 with the approval of an HCV specific RNA polymerase inhibitor, sofosbuvir. Sofosbuvir not only increased the response rate when combined with peginterferon and ribavirin, but also allowed for interferon-free treatment when combined with ribavirin, HCV protease inhibitors or a new class of agents that antagonized HCV NS5A activity. In 2014, all-oral HCV specific antiviral regimens were approved that yielded response rates in excess of 95% in patients with genotype 1. Furthermore, successful therapy required only 8 to 12 weeks of treatment in most patients and were extremely well tolerated. These all-oral regimens revolutionized therapy of hepatitis C, allowing treatment of virtually all patients regardless of severity of illness or co-morbid conditions with few side effects and durations of therapy of 8, 12 or 24 weeks. Other all oral regimens, including treatments for the less common genotypes of hepatitis C began to become available in 2015, 2016 and 2017. The several classes of agents that are combined in either a two-, three- or four-drug regimens include HCV RNA polymerase inhibitors (nucleoside and nonnucleoside), HCV NS5A antagonists and the HCV protease inhibitors. Several of these drug combinations have been formulated as single tablet or co-packaged regimens. These combination products made therapy easier to apply, but also resulted in the withdrawal of less successful agents, including boceprevir, telaprevir, daclatasvir, simeprevir and the four-drug combination of ombitasvir, dasabuvir, paritaprevir and ritonavir (Viekira Pak). Most currently used regimens are given for 8 to 12 weeks and yield response rates of 98% or more (Epclusa, Mavyret and Zepatier). Widespread application of these therapies to patients with chronic hepatitis C will likely decrease the morbidity and mortality of this disease and make significant inroads into decreasing the burden of chronic liver disease, cirrhosis, and hepatocellular carcinoma worldwide.

The following drug records are discussed individually, or as a class or as a part of combination therapies:

- Interferon Based Therapies
  - Alpha Interferon and Peginterferon, Ribavirin
- HCV NS5A Inhibitors
  - Daclatasvir, Elbasvir, Ledipasvir, Ombitasvir, Pibrentasvir, Velpatasvir
- HCV NS5B (Polymerase) Inhibitors
  - Dasabuvir, Sofosbuvir
- HCV Protease Inhibitors
  - Asunaprevir, Boceprevir, Glecaprevir, Grazoprevir, Paritaprevir, Simeprevir, Telaprevir, Voxilaprevir
- Combination Therapies
  - Epclusa, Harvoni, Mavyret, Technive, Viekira Pak, Vosevi, Zepatier

## ANNOTATED BIBLIOGRAPHY

References updated: 07 February 2022

Pawlotsky JM, Feld JJ, Zeuzem S, Hoofnagle JH. (2015). From non-A, non-B hepatitis to hepatitis C virus cure. J Hepatol. (History of the development of therapy for chronic hepatitis C starting with the discovery of a third form of viral hepatitis, through early days of use of interferon alfa, the addition of ribavirin and development of peginterferon, concluding with the arrival of direct acting antiviral agents which in combination yielded response rates of more than 95% with well tolerated regimens of 8 and 12 weeks).
Schinazi R, Halfon P, Marcellin P, Asselah T. (2014). HCV direct-acting antiviral agents: the best interferon-free combinations. Liver Int. (Summary of safety and efficacy of various all-oral regimens for therapy of hepatitis C; does not discuss hepatic decompensation, hepatotoxicity or ALT elevations during therapy).
European Association for Study of Liver. (2015). EASL Recommendations on Treatment of Hepatitis C 2015. J Hepatol. (Guidelines for the antiviral therapy of chronic hepatitis C from the European liver clinical, academic and research society).
AASLD/IDSA HCV Guidance Panel. (2015). Hepatitis C guidance: AASLD-IDSA recommendations for testing, managing, and treating adults infected with hepatitis C virus. Hepatology. (Guidelines for the antiviral therapy of chronic hepatitis C from the US liver and infectious diseases research and academic societies).
AASLD. https://www.hcvguidelines.org/ (Web-based and regularly updated guidelines for the antiviral therapy of chronic hepatitis C from the American Association for the Study of Liver Diseases and the Infectious Diseases Society of America).
Feld JJ, Jacobson IM, Hezode C, Asselah T, Ruane PJ, Gruener N, Abergel A, et al. (2015). Sofosbuvir and velpatasvir for HCV genotype 1, 2, 4, 5 and 6 infection. N Engl J Med. (Among 741 patients with chronic hepatitis C, genotype 1, 2, 4, 5, or 6, who were treated with a placebo [n=91] vs a single tablet, fixed combination of sofosbuvir and velpatasvir [n=624] once daily for 12 weeks, SVR rates were 0% vs 99% and serious adverse events occurred in none vs 2% on antiviral therapy, but no patient had a liver related serious adverse event or death).
Foster GR, Afdhal N, Roberts SK, Brau N, Gane EJ, Pianko S, Lawitz E, et al. (2015). Sofosbuvir and velpatasvir for HCV genotype 2 and 3 infection. N Engl J Med. (Among 266 patients with chronic hepatitis C, genotype 2 treated with sofosbuvir and velpatasvir vs ribavirin for 12 weeks, SVR rates were 99% vs 94% and adverse events were similar; among 544 patients with genotype 3 infection treated with sofosbuvir and velpatasvir for 12 weeks vs sofosbuvir and ribavirin for 24 weeks, the SVR rates were 97% vs 82%; adverse events were more frequent with ribavirin and no patient had a liver related serious adverse event or death).
Curry MP, O’Leary JG, Bzowej N, Muir AJ, Korenblat KM, Fenkel JM, Reddy R, Lawitz E, et al. (2015). Sofosbuvir and velpatasvir for HCV in patients with decompensated cirrhosis. N Engl J Med. (Among 267 patients with chronic hepatitis C and decompensated cirrhosis who were treated with sofosbuvir and velpatasvir for 12 or 24 weeks vs the combination with ribavirin for 12 weeks, SVR rates ranged from 83-94%; serious adverse events occurred in 18%, early discontinuation in 3% and death in 3% [4 from sepsis and 2 liver failure]).
Bourlière M, Gordon SC, Flamm SL, Cooper CL, Ramji A, Tong M, Ravendhran N, et al., POLARIS-1 and POLARIS-4 Investigators. (2017). Sofosbuvir, velpatasvir, and voxilaprevir for previously treated HCV infection. N Engl J Med. (Among 708 patients with chronic hepatitis C and previous therapy direct acting antivirals, SVR rates were 98% for sofosbuvir-velpatasvir-voxilaprevir vs 91% with sofosbuvir-velpatasvir alone and adverse events more frequent with triple therapy included headache, diarrhea and nausea; only one patient had an ALT elevation above 5 times ULN).
Zeuzem S, Foster GR, Wang S, Asatryan A, Gane E, Feld JJ, Asselah T, et al. (2018). Glecaprevir-pibrentasvir for 8 or 12 weeks in HCV genotype 1 or 3 infection. N Engl J Med. (Among 1208 patients with chronic hepatitis C without cirrhosis who were treated with glecaprevir and pibrentasvir for 8 or 12 weeks, SVR rates were 99% with 8 weeks of therapy in genotype 1 and 95% with 8 or 12 weeks of therapy in genotype 3 infected patients and there were no ALT elevations above 5 times ULN, no instances of decompensated liver disease or early termination of therapy for hepatic adverse events).
Brown RS, Buti M, Rodrigues L, Chulanov V, Chuang WL, Aguilar H, Horváth G, et al. (2020). Glecaprevir/pibrentasvir for 8 weeks in treatment-naïve patients with chronic HCV genotypes 1-6 and compensated cirrhosis: The EXPEDITION-8 trial. J Hepatol. (Among 343 patients with chronic hepatitis C and compensated cirrhosis treated with Mavyret for 8 weeks, the overall SVR rate was 98%, and 46% had adverse events, 2% serious, no patient developed hepatic decompensation, and only one had an isolated single elevation of ALT above 5 times ULN).
Nangia G, Vierling JM, Kwo P, Brown DD, Klopfer SO, Robertson MN, Haber BA, et al. (2020). Safety and tolerability of elbasvir/grazoprevir in chronic hepatitis C virus therapy: Integrated analysis from clinical trials. J Viral Hepat. (Among 1743 adults with chronic hepatitis C treated with elbasvir and grazoprevir for 12 weeks in 12 clinical trials, the overall adverse event rate was 61%, considered drug related in 28%, serious in 2.1%, and resulting in early discontinuation in 0.7%; most common were headache [11%], fatigue [9%], nasopharyngitis [6%], nausea [5%], diarrhea [9%] and ALT elevations [5%], which were above 5 times ULN in 1.5%; adverse event rates were similar in cirrhotic and non-cirrhotic subjects).